# Sitagliptin

## OVERVIEW

### Introduction

Sitagliptin is a dipeptidyl peptidase-4 (DPP-4) inhibitor which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other oral hypoglycemic agents. Only rare isolated reports of liver injury due to sitagliptin have been published.

### Background

Sitagliptin (sit" a glip' tin) is an inhibitor of dipeptidyl peptidase-4, which is the major enzyme responsible for the degradation of glucagon-like peptide-1 (GLP-1), an important gastrointestinal hormone (incretin) that increases glucose dependent insulin secretion by the pancreas. By prolonging the effect of GLP-1, sitagliptin increases insulin levels and lowers blood glucose and helps in glycemic control in patients with type 2 diabetes. Sitagliptin was approved for use in the United States in 2006 and was the first DPP-4 inhibitor introduced into clinical practice. The current indications are for management of glycemic control in type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents or insulin. Sitagliptin is available in tablets of 25, 50 and 100 mg under the brand name Januvia and in fixed combinations with metformin under the name Janumet. The typical dose of sitagliptin in adults is 100 mg once daily. Adverse reactions to sitagliptin are not common, but may include headache, nausea, arthralgia and rash. Hypoglycemia is uncommon with sitagliptin alone (<1%), but occurs in higher rates when it is combined with other oral hypoglycemic agents. Sitagliptin has also been linked to rare instances of bullous pemphigoid and acute pancreatitis that can be severe and even fatal.

### Hepatotoxicity

Liver injury due to sitagliptin is rare. In large clinical trials, serum enzyme elevations were no more common with sitagliptin therapy (0.5%) than with placebo (0.4%), and no instances of clinically apparent liver injury were reported. Since licensure, instances of serum enzyme elevations attributed to sitagliptin have been reported to the FDA and the sponsor. A single case report of clinically apparent liver injury has been published, but in a patient who also had hepatitis C. The pattern of serum enzyme elevations was hepatocellular and peak serum bilirubin was 9.4 mg/dL, with a rapid recovery upon stopping sitagliptin. Immunoallergic features and autoantibodies were absent.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury during sitagliptin therapy is not known. The drug is mostly excreted unchanged and only a small proportion (~15%) is metabolized in the liver, largely by the cytochrome P450 system (CYP 3A4 and 2C8).

### Outcome and Management

The instances of liver injury associated with the DPP-4 inhibitors have been self-limited and resolved rapidly upon stopping the medication. The similarity in chemical structure among the DPP-4 inhibitors suggests that there may be cross sensitivity to hepatic injury among the different agents, but this has not been reported. However, the other common antidiabetic medications in use should be tolerated without increased risk of liver injury.

References regarding the hepatotoxicity and safety of the DPP-4 inhibitors are given in the Overview section of DPP-4 Inhibitors (updated 03 January 2018).

Drug Class: Antidiabetic Agents, Incretin-Based Drugs

Other Drugs in the Subclass, Dipeptidyl Peptidase-4 (DPP-4) Inhibitors: Alogliptin, Linagliptin, Saxagliptin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sitagliptin – Januvia®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sitagliptin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sitagliptin | 486460-32-6 | C16-H15-F6-N5-O | Sitagliptin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Sitagliptin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Sitagliptin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sitagliptin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sitagliptin)